# Rabeprazole

## OVERVIEW

### Introduction

Rabeprazole is a proton pump inhibitor (PPI) and a potent inhibitor of gastric acidity used in the therapy of gastroesophageal reflux and peptic ulcer disease. Rabeprazole therapy is associated with a low rate of transient and asymptomatic serum aminotransferase elevations and is a rare cause of clinically apparent liver injury.

### Background

Rabeprazole (ra bep' ra zole), like other PPIs, binds to and inactivates the H+/K+-ATPase of gastric parietal cells, causing inhibition of the proton pump that transports H+ into the gastric lumen, the final common step in gastric acid production. Rabeprazole is a prodrug and is converted to the active form in the acidic secretory canaliculi of parietal cells. Because the inhibition is irreversible, acid secretion is suppressed for 24 to 48 hours, until new proton pump molecules have been synthesized and transported to the cell membrane. Rabeprazole was the third PPI approved for use in the United States (1999) and is widely used in the therapy of acid-peptic disease, including duodenal and gastric ulcer disease and gastroesophageal reflux. Rabeprazole is available in delayed release tablets of 20 mg in generic forms and under the brand name Aciphex. The typical dose for duodenal ulcer disease is 20 mg once daily for 4 to 8 weeks, with similar doses for long term maintenance therapy. Twice daily doses are used for more severe cases of gastrointestinal reflux and peptic ulcer disease, and doses of up to 120 mg daily for Zollinger-Ellison syndrome. Rabeprazole is very well tolerated. Side effects are uncommon and usually mild; they may include nausea, vomiting, abdominal discomfort, constipation, diarrhea, flatulence, skin rash, headaches and dizziness. Severe side effects are rare but can include hypersensitivity reactions. Long-term use of rabeprazole may be associated with bone fractures, acute interstitial nephritis, lupus erythematosus, vitamin B12 deficiency and hypomagnesemia.

### Hepatotoxicity

Despite its wide use, rabeprazole has only rarely been associated with hepatic injury. In large scale, long term trials of rabeprazole, serum ALT elevations occurred in less than 1% of patients and at rates similar to those with placebo or comparator drugs. In large case series of drug induced liver injury, rabeprazole has accounted for few instances of symptomatic acute liver injury. Only a few cases of clinically apparent liver disease due to rabeprazole have been published and the characteristics of the injury have not been well defined, but appear to be similar to the features of hepatic injury associated with other proton pump inibitors. Clinically apparent liver injury due to proton pump inhibitors typically arises within the first 4 weeks of treatment with symptoms of jaundice, nausea and fatigue and a hepatocellular or mixed pattern of serum enzyme elevations. Recovery is typically rapid upon withdrawal of the agent. Rash, fever and eosinophilia are rare, as is autoantibody formation. Instances of recurrence on rechallenge have been reported.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The acute onset and rapid recurrence of hepatic injury with proton pump inhibitors suggests a hypersensitivity reaction, but may merely reflect altered metabolism or acute toxicity of a metabolic byproduct. Rabeprazole is metabolized predominantly by the CYP 2C19 microsomal drug-metabolizing enzyme and may interfere with clearance of other agents metabolized in a similar fashion.

### Outcome and Management

The mild and asymptomatic elevations in serum aminotransferase that have been observed during rabeprazole therapy are usually transient and may resolve even without dose modification. Clinically apparent liver injury due to rabeprazole is rare, but calls for prompt withdrawal of the agent. Cases of acute liver failure due to proton pump inhibitor use have been described, but not specifically with rabeprazole. Recurrence of acute liver injury on rechallenge after an initial episode of clinically apparent liver injury with rabeprazole has been reported. There is no information about cross reactivity among the various PPIs after rabeprazole hepatotoxicity, but the PPIs all share a benzimidazole structure, and caution should be used in attempting to reintroduce another PPI after clinically apparent PPI associated hepatic injury.

Drug Class: Antiulcer Agents

Other Drugs in the Subclass, Proton Pump Inhibitors: Dexlansoprazole, Esomeprazole, Lansoprazole, Omeprazole, Pantoprazole

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Rabeprazole – Generic, Aciphex®

DRUG CLASS

Antiulcer Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Rabeprazole)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Rabeprazole | 117976-90-6 | C18-H21-N3-O3-S.Na | Rabeprazole Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 15 April 2019

Zimmerman HJ. Proton pump inhibitors. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 720-1. (Expert review of hepatotoxicity published in 1999 states that aminotransferase elevations occur in ~1% of PPI treated patients, but only 1 case of acute liver injury has been reported with omeprazole, none with the more recently released lansoprazole and pantoprazole).
Sharkey KA, McNaughton WK. Pharmacotherapy of gastric acidity, peptic ulcers, and gastroesophageal reflux disease. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 921-44. (Textbook of pharmacology and therapeutics).
Arnold R. Safety of proton pump inhibitors--an overview. Aliment Pharmacol Ther 1994; 8 Suppl 1: 65-70. (Side effects of PPIs are uncommon and no more frequent than with cimetidine and ranitidine; "Omeprazole had no clinically relevant effects of laboratory values including...liver function"). 8180297
Reilly JP. Safety profile of the proton-pump inhibitors. Am J Health Syst Pharm 1999; 56 (23 Suppl 4): S11-7. (Review of side effects of proton pump inhibitors, including long term tolerance). 10597119
Martin RM, Dunn NR, Freemantle S, Shakir S. The rates of common adverse events reported during treatment with proton pump inhibitors used in general practice in England: cohort studies. Br J Clin Pharmacol 2000; 50: 366-72. (Prescription event monitoring of common side effects of omeprazole, lansoprazole and pantoprazole from the UK found low rates of diarrhea [0.18-0.39/1000 days], abdominal pain [0.17-.21], nausea [0.16-0.22] and headache [0.10-0.17]; no analysis of liver toxicities). 11012560
Johnstone D, Berger C, Fleckman P. Acute fulminant hepatitis after treatment with rabeprazole and terbinafine. Arch Intern Med 2001; 161: 1677-8. (46 year old developed jaundice 4 weeks after starting terbinafine, rabeprazole and citalopram [bilirubin 1.2, ALT >3000 U/L], biopsy showing submassive necrosis, resolving in 2 months; authors suggest that rabeprazole rather than terbinafine was the cause). 11434801
Andrade RJ, Lucena MI. Acute fulminant hepatitis after treatment with rabeprazole and terbinafine: is rabeprazole the culprit? Arch Intern Med 2002; 162: 360-1. (Letter in response to Johnstone [2001] argues that terbinafine rather than rabeprazole was the cause of the hepatotoxicity). 11822934
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to an H2 blocker or proton pump inhibitor). 15390328
de Abajo FJ, Montero D, Madurga M, García Rodríguez LA. Acute and clinically relevant drug-induced liver injury: a population based case-control study. Br J Clin Pharmacol 2004; 58: 71-80. (Analysis of General Practice Research Database from UK on 1.6 million persons from 1994-2000 found 128 cases of drug induced liver injury [2.4/100,000 person years]; 3 cases were attributed to cimetidine for an odds ratio of 2.0 compared to controls [n=5000], which was not statistically significant; rabeprazole was not discussed). 15206996
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Survey of all cases of DILI with fatal outcome from Swedish Adverse Drug Reporting system from 1966-2002; 103 cases were identified and judged as highly probable, probable or possible; 1 case was attributed to ranitidine, 1 to omeprazole, but none to other antiulcer agents). 16165719
Salgueiro E, Rubio T, Hidalgo A, Manso G. Safety profile of proton pump inhibitors according to the spontaneous reports of suspected adverse reactions. Int J Clin Pharmacol Ther 2006; 44: 548-56. (Analysis of PPI related reports to Spanish Pharmacovigilance Database during 2004 found 58 reports of liver injury from omeprazole [n=36], lansoprazole [7], pantoprazole [12], rabeprazole [2] and esomeprazole [1], correlating somewhat with relative number of prescriptions; 82% were taking other medications; most resolved uneventually). 17176621
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther 2007; 25:1401-9. (Population based survey of 126 cases of acute liver injury due to drugs between 1993-1999 in Spain; 8 were attributed to ranitidine alone [incidence 5.1/100,000 person-years] and 5 to omeprazole alone [2.1/100,000]). 17539979
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 2 were attributed to ranitidine, none to cimetidine or the proton pump inhibitors). 18955056
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (World wide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, but no antiulcer medication was listed in the top 40 causes). 21039766
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but no case was linked to an antiulcer medication). 20949552
Aktaş B, Başar Ö, Altinbaş A, Ekiz F, Yüksel O. Rabeprazole-induced acute cholestatic liver injury. Turk J Gastroenterol 2012; 23: 309-10. (46 year old man developed jaundice one week after starting rabeprazole [bilirubin 8.3 mg/dL, ALT 374 U/L, Alk P 470 U/L], with resolution within 15 days of stopping and recurrence of jaundice within 3 days of restarting). 22798130
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to rabeprazole, despite it being among the 10 most prescribed medications in Iceland). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to rabeprazole or other proton pump inhibitors). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 3 [0.3%] were attributed to proton pump inhibitors [omeprazole, esomeprazole and lansoprazole], but none to rabeprazole). 25754159
Tsai CF, Chen MH, Wang YP, Chu CJ, Huang YH, Lin HC, Hou MC, et al. Proton pump inhibitors increase risk for hepatic encephalopathy in patients With cirrhosis in a population study. Gastroenterology 2017; 152: 134-41. (Analysis of the Taiwan National Health Insurance database found a higher rate of proton pump inhibitor use among patients with cirrhosis who developed hepatic encephalopathy [38%: 445 of 1166] compared to a matched group with cirrhosis who did not [rate not provided]; the relative risk was raised for all agents except for rabeprazole). 27639806
Weersink RA, Bouma M, Burger DM, Drenth JPH, Froukje Harkes-Idzinga S, Hunfeld NGM, Metselaar HJ, et al. Safe use of proton pump inhibitors in patients with cirrhosis. Br J Clin Pharmacol 2018; 84: 1806-20. (Systematic review of 69 publications in the literature suggested that doses of proton pump inhibitors should be reduced in patients with cirrhosis and only esomeprazole used in those with Child Pugh Class C cirrhosis, plasma levels of rabeprazole being elevated in patients with cirrhosis, 2-fold with Child Pugh class A, 3-fold with class B and 5-fold with class C). 29688583

## OTHER REFERENCE LINKS

1. Recent References on Rabeprazole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Rabeprazole/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Rabeprazole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Rabeprazole)